# Resveratrol

## OVERVIEW

### Introduction

Resveratrol is a plant polyphenol found in high concentrations in red grapes that has been proposed as a treatment for hyperlipidemia and to prevent fatty liver, diabetes, atherosclerosis and aging. Resveratrol use has been associated with rare instances of serum enzyme elevations during therapy but has not been convincingly linked to episodes of clinically apparent liver injury.

### Background

Resveratrol is a natural plant polyphenol (3,5,4’-trihydroxystilbene) that is found in highest concentrations in the skin of red grapes and other fruits (mulberries, blueberries, blackberries). In cell culture, resveratrol has antiinflammatory, cytoprotective, and antineoplastic properties which can be reproduced in several animal models. In model systems such as yeast (S. cerevisiae), worms (C. elegans), and fruit flies (Drosophila), chronic administration of resveratrol extends lifespan in a manner similar to caloric restriction. These results were somewhat controversial, but subsequent studies in several mammalian species supported the finding to some extent. Thus, resveratrol extended lifespan in mice fed a high fat diet (but not in normal mice), seemingly by counteracting the detrimental effects of the diet, and improving insulin sensitivity and mitochondrial function. The bases for the beneficial effects of resveratrol are unclear. Resveratrol has direct antioxidant effects, but also stimulates expression of antioxidant enzymes and the activity of sirtuin 1 (SIRT1) and adenosine monophosphate activated protein kinase (AMP-K), both of which have major effects on glucose and fat metabolism and may play a role in aging. Resveratrol is available without prescription as a nutritional supplement in multiple preparations and doses. In human trials, doses of resveratrol have ranged from 20 mg to 5 gm daily, but a typical over-the-counter recommended dose is 500 mg twice daily. Importantly, the purity of commercial products is rarely well defined, its oral bioavailability is poor and the component responsible for its activity is not known. Thus, resveratrol exists in both trans and cis configuration and the major form found in plasma is a sulfated or glucuronidal conjugate rather than free resveratrol. At present, there is no conclusive evidence that resveratrol has beneficial effects in humans. On the other hand, it has few if any side effects. Side effects may include minor gastrointestinal upset, nausea, headache and fatigue and possible supplement-drug interactions with estrogens and anticoagulants.

### Hepatotoxicity

There have been multiple trials of resveratrol in human subjects, but the dose regimen and duration of therapy has varied greatly and many trials lacked information on adverse events, ALT elevations, and hepatotoxicity. Nevertheless, in most studies there was no mention of serum ALT elevations or only rare and mild-to-moderate increases that were asymptomatic and resolved rapidly upon stopping therapy. However, in studies using high doses of resveratrol (1.5 to 3.0 grams daily), average serum ALT and AST levels rose slightly during therapy and promptly fell into the normal range with stopping. There were, however, no instances of serum ALT elevations with jaundice or symptoms. Furthermore, despite widespread clinical use, there have been no published reports of clinically apparent liver injury attributed to resveratrol. In large case series and nationwide registries on herbal induced liver injury, resveratrol is not listed as a cause. Thus, hepatotoxicity due to resveratrol must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Resveratrol – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://www.nlm.nih.gov/medlineplus/druginfo/natural/307.html)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Resveratrol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Resveratrol | 501-36-0 | C14-H12-O3

## ANNOTATED SELECTIVE BIBLIOGRAPHY

References updated: 30 November 2024

Abbreviations used: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not resveratrol).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 631-58. (Review of hepatotoxicity of herbal and dietary supplements; no mention of resveratrol).
Resveratrol. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 19-26. (Compilation of short monographs on herbal medications and dietary supplements).
Stedman C. Herbal hepatotoxicity. Semin Liver Dis 2002; 22: 195-206. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions). 12016550
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation). 12879994
Baur JA, Pearson KJ, Price NL, Jamieson HA, Lerin C, Kalra A, Prabhu VV, et al. Resveratrol improves health and survival of mice on a high-calorie diet. Nature 2006; 444: 337-42. (In mice fed a high caloric diet long term, resveratrol [22 mg/kg/day] supplementation increased life span, improved insulin sensitivity, and decreased hepatic fat). 17086191
Pfluger PT, Herranz D, Velasco-Miguel S, Serrano M, Tschöp MH. Sirt1 protects against high-fat diet-induced metabolic damage. Proc Natl Acad Sci USA 2008; 105: 9793-8. (Mice with overexpression of SIRT1 were protected from the metabolic effects of a high fat diet, and had improved insulin sensitivity and less hepatic fat and inflammation with lower levels of inflammatory cytokines and higher antioxidant enzymes). 18599449
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but no case attributed to resveratrol alone or in combination with other agents). 18955056
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals; none were due to resveratrol). 19159172
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-382. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; resveratrol is not listed as a potential hepatotoxin). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no instance was linked to resveratrol). 19650152
Almeida L, Vaz-da-Silva M, Falcão A, Soares E, Costa R, Loureiro AI, Fernandes-Lopes C, et al. Pharmacokinetic and safety profile of trans-resveratrol in a rising multiple-dose study in healthy volunteers. Mol Nutr Food Res 2009 May; 53 Suppl 1: S7-15. (Pharmacokinetic study of 4 doses of resveratrol vs placebo given every 4 hours for 48 hours in 40 volunteers; side effects included headache, dyspepsia and dizziness; "no clinically significant abnormalities were found in the laboratory parameters"). 19194969
Brown VA, Patel KR, Viskaduraki M, Crowell JA, Perloff M, Booth TD, Vasilinin G, et al. Repeat dose study of the cancer chemopreventive agent resveratrol in healthy volunteers: safety, pharmacokinetics, and effect on the insulin-like growth factor axis. Cancer Res 2010; 70: 9003-11. (Pharmacokinetic study of 4 doses of resveratrol [0.5-4 gm daily] for 29 days in 40 volunteers found occasional minor abdominal discomfort, nausea, diarrhea, flatulence and dizziness with higher doses, but no serious adverse events). 20935227
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not resveratrol). 20949552
Bishayee A, Darvesh AS, Politis T, McGory R. Resveratrol and liver disease: from bench to bedside and community. Liver Int 2010; 30: 1103-14. (Extensive review of the in vitro and in vivo studies of resveratrol as a hepatoprotective agent against several forms of experimental liver injury, and the challenges of clinical studies of resveratrol in humans). 20557453
Smoliga JM, Baur JA, Hausenblas HA. Resveratrol and health – A comprehensive review of human clinical trials. Mol Nutr Food Res 2011; 55: 1129-41. (Review of the literature on pharmacokinetics, efficacy and safety of resveratrol in humans; few studies have been done, but none have reported severe adverse events or significant toxicities). 21688389
Howells LM, Berry DP, Elliott PJ, Jacobson EW, Hoffmann E, Hegarty B, Brown K, et al. Phase I randomized, double-blind pilot study of micronized resveratrol (SRT501) in patients with hepatic metastases—safety, pharmacokinetics, and pharmacodynamics. Cancer Prev Res (Phila) 2011; 4: 1419-25. (9 subjects scheduled to undergo hepatectomy for cancer metastases were given a micronized resveratrol [5 gm/day] or placebo for 14 days; peak plasma levels were variable and achieved in 2-4 hours with plasma half-life of 1 hour, and detectable levels in tissue at surgery). 21680702
Walle T. Bioavailability of resveratrol. Ann N Y Acad Sci 2011; 1215: 9-15. (Resveratrol exists as trans and cis isomers and is well absorbed orally but is rapidly metabolized by intestine and liver to sulfate and glucuronide conjugates). 21261636
Yoshino J, Conte C, Fontana L, Mittendorfer B, Imai S, Schechtman KB, Gu C, Kunz I, et al. Resveratrol supplementation does not improve metabolic function in nonobese women with normal glucose tolerance. Cell Metab 2012; 16: 658-64. (Controlled study of resveratrol [75 mg/day] vs placebo in 29 normal volunteers, found no change in weight, insulin sensitivity, serum enzyme levels or in SIRT1 expression [in muscle and adipose tissue] or AMP-K activity [in muscle tissue] after 12 weeks of therapy). 23102619
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements; none implicated resveratrol). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury enrolled in a US prospective study between 2004 and 2013, resveratrol was not implicated in any case). 25043597
Chachay VS, Macdonald GA, Martin JH, Whitehead JP, O'Moore-Sullivan TM, Lee P, Franklin M, et al. Resveratrol does not benefit patients with nonalcoholic fatty liver disease. Clin Gastroenterol Hepatol. 2014;12:2092-2103. (Among 20 overweight or obese men with hepatic steatosis treated with resveratrol [1500 mg] or placebo twice daily for 8 weeks, there was no change in body weight, hepatic steatosis, fasting blood glucose or lipid levels, while serum ALT and AST increased [median ALT rising from 25 to 63 U/L, AST from 35 to 45 U/L], with minimal increases in serum bilirubin and cytokeratin 18 but no symptoms; these changes were attributed to the high doses used). 24582567
Turner RS, Thomas RG, Craft S, van Dyck CH, Mintzer J, Reynolds BA, Brewer JB, et al; Alzheimer's Disease Cooperative Study. A randomized, double-blind, placebo-controlled trial of resveratrol for Alzheimer disease. Neurology 2015; 85: 1383-91. (Among 119 patients with Alzheimer disease treated with resveratrol [500 mg increasing to as much as 2000 mg daily] vs placebo for 52 weeks, there was no improvement in clinical or radiologic features and adverse event rates were similar between the 2 groups; no mention of ALT levels except that "routine laboratory tests were normal"). 26362286
Yiu EM, Tai G, Peverill RE, Lee KJ, Croft KD, Mori TA, Scheiber-Mojdehkar B, et al. An open-label trial in Friedreich ataxia suggests clinical benefit with high-dose resveratrol, without effect on frataxin levels. J Neurol 2015; 262: 1344-53. (Among 24 patients with Friedreich ataxia treated with resveratrol [1 gm vs 5 gm daily] for 12 weeks, adverse events more frequent with the higher dose included diarrhea [71% vs 8%], nausea [36% vs 8%] and skin rash [29% vs none], and 1 subject developed liver test abnormalities 4 weeks after starting high dose resveratrol [bilirubin not provided, ALT <2 times ULN, Alk P 4 times ULN], resolving 8 weeks after stopping). 25845763
Chen S, Zhao X, Ran L, Wan J, Wang X, Qin Y, Shu F, et al. Resveratrol improves insulin resistance, glucose and lipid metabolism in patients with non-alcoholic fatty liver disease: a randomized controlled trial. Dig Liver Dis 2015; 47: 226-32. (Among 60 patients with nonalcoholic fatty liver disease treated with resveratrol [300 mg twice daily] vs placebo for 3 months, median ALT levels decreased by 7 vs 1 U/L in placebo recipients, while ultrasound graded hepatic fat did not change). 25577300
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products, does not list resveratrol). 27070596
Heebøll S, Kreuzfeldt M, Hamilton-Dutoit S, Kjær Poulsen M, Stødkilde-Jørgensen H, Møller HJ, Jessen N, et al. Placebo-controlled, randomised clinical trial: high-dose resveratrol treatment for non-alcoholic fatty liver disease. Scand J Gastroenterol. 2016;51:456-64. (Among 28 adults with fatty liver and raised serum ALT levels treated with resveratrol [500 mg] or placebo 3 times daily for 6 months, there were no differences in changes in body weight, hepatic steatosis, blood glucose levels, lipids, and serum ALT and AST levels between the two arms; 1 treated patient developed fever and lymphopenia that resolved on stopping and recurred on restarting and another developed an asymptomatic rise in ALT levels [from 150 to ~380 U/L] that resolved despite continuing therapy). 26784973
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss resveratrol). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of resveratrol). 29307848
Asghari S, Rafraf M, Farzin L, Asghari-Jafarabadi M, Ghavami SM, Somi MH. Effects of pharmacologic dose of resveratrol supplementation on oxidative/antioxidative status biomarkers in nonalcoholic fatty liver disease patients: a randomized, double-blind, placebo-controlled Trial. Adv Pharm Bull. 2018;8:307-317. (Among 60 overweight or obese adults with nonalcoholic fatty liver treated with resveratrol [600 mg] or placebo daily for 12 weeks, there were no significant changes in markers of oxidative stress or in serum levels of ALT, AST, Alk P or GGT; no mention of adverse events or individual elevations in serum ALT or AST). 30023333
Kantartzis K, Fritsche L, Bombrich M, Machann J, Schick F, Staiger H, Kunz I, et al. Effects of resveratrol supplementation on liver fat content in overweight and insulin-resistant subjects: A randomized, double-blind, placebo-controlled clinical trial. Diabetes Obes Metab. 2018;20:1793-1797. (Among 108 overweight or obese adults with fatty liver and insulin resistance treated with resveratrol [150 mg] or placebo daily for 12 weeks, there were no significant differences in changes in total, liver, or visceral fat [by magnetic resonance spectroscopy], fasting glucose or HbA1c levels, HOMA-IR, blood pressure, or liver enzymes levels between the two groups). 29484808
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; no mention of resveratrol). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while resveratrol was not mentioned). 33434654
Kasprzak-Drozd K, Niziński P, Kasprzak P, Kondracka A, Oniszczuk T, Rusinek A, Oniszczuk A. Does resveratrol improve metabolic dysfunction-associated steatotic liver disease (MASLD)? Int J Mol Sci. 2024;25:3746. (Resveratrol showed promising effects in vitro and in animal models of nonalcoholic steatohepatitis [NASH], possibly by inhibiting the NF-κB pathway, activating SIRT1 and AMP kinase, modifying the microbiome, or decreasing inflammation; but clinical studies “have yielded inconclusive results”). 38612556
Keramatzadeh S, Hosseini SA, Majdinasab N, Cheraghian B, Zilaee M. Effects of resveratrol supplementation on inflammatory markers, fatigue scale, fasting blood sugar and lipid profile in relapsing-remitting multiple sclerosis patients: a double-blind, randomized placebo-controlled trial. Nutr Neurosci. 2024:1-9. Epub ahead of print. (Among 55 patients with multiple sclerosis treated with resveratrol [500 mg] vs placebo daily for 8 weeks, there were significant decreases in serum malondialdehyde and tumor necrosis factor alpha levels with treatment but no significant changes in fatigue, food intake, body weight, lipids or glucose levels compared to placebo; no mention of adverse events, ALT levels, or hepatotoxicity). 39565038
Ahmadi-Mousavi B, Karami-Mohajeri S, Dabaghzadeh F, Soltani M, Oghabian Z, Sharifi H. The effects of resveratrol in a randomized clinical trial on drug-induced hyperlipidemia and psychiatric factors in people living with HIV. Curr HIV Res. 2024 Nov 8. Epub ahead of print. (Among 41 adults with HIV infection treated with resveratrol [500 mg] or placebo once daily for one month, there were no differences in changes in cholesterol or triglyceride levels or in symptoms or measures of quality of life and sleep quality; no mention of adverse events or ALT levels). 39528454
Nguyen C, Coudeyre E, Boutron I, Baron G, Daste C, Lefèvre-Colau MM, Sellam J, et al. Oral resveratrol in adults with knee osteoarthritis: A randomized placebo-controlled trial (ARTHROL). PLoS Med. 2024;21:e1004440. (Among 142 patients with painful knee osteoarthritis treated with resveratrol [40 mg] or placebo twice daily for 6 months, there were no differences in knee pain between the two groups, and total and severe adverse events rates were similar, with none judged to be related to the intervention; no mention of ALT levels or hepatotoxicity). 39137167
Erol Doğan Ö, Karaca Çelik KE, Baş M, Alan EH, Çağın YF. Effects of Mediterranean diet, curcumin, and resveratrol on mild-to-moderate active ulcerative colitis: a multicenter randomized clinical trial. Nutrients. 2024;16:1504. (Among 48 patients with ulcerative colitis placed on a “Mediterranean diet” and treated with curcumin [1600 mg], resveratrol [500 mg] or placebo daily for 8 weeks, improvements in CRP and sedimentation rate and in health related quality of life and inflammatory bowel disease symptom scores occurred in all three groups with no additional effects in those receiving resveratrol or curcumin; no mention of adverse events or ALT levels). 38794742

## OTHER REFERENCE LINKS

1. Recent References on Resveratrol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Resveratrol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Resveratrol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Resveratrol)